# Lesinurad

## OVERVIEW

### Introduction

Lesinurad is a selective inhibitor of uric acid reabsorption which is used in combination with other agents in the therapy of gout. Lesinurad has had limited clinical use, but has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Lesinurad (le sin' ure ad) is a selective inhibitor of the uric acid transporter (URAT1) in the kidneys that is responsible for reabsorption or urate in the distal tubules. Inhibition of uric acid reabsorption causes a decrease in serum levels of uric acid, but an increase in urinary urate. Lesinurad was found to lower uric acid levels in patients with gout and hyperuricemia who had not achieved adequate control of symptoms or uric acid levels with a xanthine oxidase inhibitor (allopurinol or febuxostat) alone. Lesinurad was approved in the United States in 2015 for use in combination with a xanthine oxidase inhibitor in patients with gout and hyperuricemia. Lesinurad is available in tablets of 200 mg under the brand name Zurampic. The typical dose is 200 mg once daily in combination with allopurinol or febuxostat. Side effects are not common with lesinurad, but can include headache, upper respiratory tract infections, reflux esophagitis and elevations in serum creatinine. Severe adverse reactions include acute renal failure, particularly in patients who are not receiving a xanthine oxidase inhibitor.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were rare during lesinurad therapy and no more common than with placebo, and no instances of clinically apparent liver injury attributable to lesinurad were reported. Clinical experience with lesinurad therapy has been limited, but there have yet to be reports of clinically apparent liver injury attributable to its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lesinurad might cause liver injury is unclear. Lesinurad is metabolized in the liver via the cytochrome P450 system, particularly CYP 2C9 and 3A and is susceptible to drug-drug interactions with substrates, inducers or inhibitors of those microsomal enzymes.

### Outcome and Management

The serum enzyme elevations during lesinurad therapy are uncommon. In situations in which ALT or AST levels rise and remain above 5 times ULN, dose modification or temporary discontinuation of lesinurad is prudent.

Drug Class: Antigout Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lesinurad – Zurampic®

DRUG CLASS

Antigout Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lesinurad)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Lesinurad | 878672-00-5 | C17-H14-Br-N3-O2-S | Lesinurad chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 May 2019

Zimmerman HJ. Drugs used to treat gout. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 542-4. (Textbook of hepatotoxicity published in 1999 and before the availability of lesinurad).
Grosser T, Smyth E, FitzGerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 685-710. (Textbook of pharmacology and therapeutics).
Fleischmann R, Kerr B, Yeh LT, Suster M, Shen Z, Polvent E, Hingorani V, et al.; RDEA594-111 Study Group. Pharmacodynamic, pharmacokinetic and tolerability evaluation of concomitant administration of lesinurad and febuxostat in gout patients with hyperuricaemia. Rheumatology (Oxford) 2014; 53: 2167-74. (Among 20 patients treated with escalating doses of lesinurad in combination with allopurinol or febuxostat, side effects included headache and dyspepsia, but there were no serious adverse events and no “treatment-related changes in clinical laboratory evaluations”). 24509406
Drugs for gout. Med Lett Drugs Ther 2014; 56 (1438): 22-4. (Update on medications for gout discusses the urate lowering agents allopurinol, febuxostat, probenecid and pegloticase, but not lesinurad). 24791281
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 8 cases were attributed to drugs used for gout [allopurinol in 7 and febuxostat in 1], but no cases were attributed to lesinurad). 25754159
Perez-Ruiz F, Sundy JS, Miner JN, Cravets M, Storgard C; RDEA594-203 Study Group. Lesinurad in combination with allopurinol: results of a phase 2, randomised, double-blind study in patients with gout with an inadequate response to allopurinol. Ann Rheum Dis 2016; 75: 1074-80. (Among 208 patients with hyperuricemia and gout treated with lesinurad [200, 400 or 600 mg] or placebo daily in addition of allopurinol, uric acid levels decreased with active drug but not placebo, and there were no serious adverse events or deaths; no mention of ALT changes or clinically apparent liver injury). 26742777
Hoy SM. Lesinurad: first global approval. Drugs 2016; 76: 509-16. (Review of the development, mechanism of action, pharmacology, clinical efficacy and safety of lesinurad shortly after its approval in the US mentions that it was “generally well tolerated” with pooled adverse event rates similar to those with placebo, with headache in 5.3% vs 4.1%, gastroesophageal reflux in 2.7% vs 0.8%, creatinine elevations in 3.9% vs 1.8%; no mention of ALT elevations or hepatotoxicity). 26861027
Bardin T, Keenan RT, Khanna PP, Kopicko J, Fung M, Bhakta N, Adler S, et al. Lesinurad in combination with allopurinol: a randomised, double-blind, placebo-controlled study in patients with gout with inadequate response to standard of care (the multinational CLEAR 2 study). Ann Rheum Dis 2017; 76 (5): 811-20. (Among 610 patients with gout an an inadequate response to allopurinol treated with lesinurad [200 or 400 mg daily] or placebo, those on lesinurad had a greater rate of uric acid control and "clinical laboratory results" excluding creatinine levels "were comparable between treatment groups"). 27821644
Saag KG, Fitz-Patrick D, Kopicko J, Fung M, Bhakta N, Adler S, Storgard C, et al. Lesinurad combined with allopurinol: randomized, double-blind, placebo-vontrolled dtudy in gout subjects with inadequate response to standard of care allopurinol (a US-based study). Arthritis Rheumatol 2017; 69: 203-12. (Among 603 patients with gout and an inadequate response to allopurinol who were started on lesinurad [200 or 400 mg daily] vs placebo, those on lesinurad had a greater rate of uric acid control and "clinical laboratory test results, including ...liver function tests... demonstrated no notable differences between the treatment groups over time"). 27564409
Lesinurad (Zurampic) for gout-associated hyperuricemia. Med Lett Drugs Ther 2016; 58 (1508): 148-50. (Concise review of the mechanism of action, clinical efficacy, safety, drug-interactions and costs of lesinurad, shortly after its approval for treament of gout associated hyperuricemia in the US, mentions creatinine but not aminotransferase elevations occurring on therapy). 27849193
Lesinurad/allopurinol (Duzallo) for gout-associated hyperuricemia. Med Lett Drugs Ther 2017; 59 (1533): 182-3. (Concise review of the efficacy, safety and costs of the fixed combination of lesinurad and allopurinol for once-daily treatment of gout; mentions renal toxicity of lesinurad and hepatotoxicity of allopurinol). 29125593
Dalbeth N, Jones G, Terkeltaub R, Khanna D, Fung M, Baumgartner S, Perez-Ruiz F. Efficacy and safety during extended treatment of lesinurad in combination with febuxostat in patients with tophaceous gout: CRYSTAL extension study. Arthritis Res Ther 2019; 21: 8. (Among 193 patients completing a 12-month controlled trial of lesinurad and febuxosat who were enrolled in an extension study for a total of 2 years, there were "no notable changes from baseline" of clinical safety laboratory values). 30616614
Perez-Gomez MV, Bartsch LA, Castillo-Rodriguez E, Fernandez-Prado R, Kanbay M, Ortiz A. Potential dangers of serum urate-lowering therapy. Am J Med 2019; 132: 457-67. (Commentary on the trend for higher mortality rates in trials of uric acid lowering drugs among patients who achieve the lowest levels, suggesting that serum uric acid values below 5.0 mg/dL may be unsafe). 30611833
Terkeltaub R, Saag KG, Goldfarb DS, Baumgartner S, Schechter BM, Valiyil R, Jalal D, et al. Integrated safety studies of the urate reabsorption inhibitor lesinurad in treatment of gout. Rheumatology (Oxford) 2019; 58: 61-9. (Pooled analysis of 3 controlled trials found no increase in renal, cardiovascular or other adverse events associated with addition of lesinurad to allopurinol). 30124941
Drugs for gout. Med Lett Drugs Ther 2019; 61 (1567): 33-7. (Concise review of medications used to treat gout; mentions that meta-analysis of 5 randomized controlled trials found that addition of lesinurad to a xanthine oxidase inhibitor did not improve clinical gout related outcomes and the fixed combination of lesinurad and allopurinol has been withdrawn from the US market). 30845096

## OTHER REFERENCE LINKS

1. Recent References on Lesinurad: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lesinurad/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lesinurad: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lesinurad)